# Atorvastatin

## OVERVIEW

### Introduction

Atorvastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy and rarely with clinically apparent acute liver injury.

### Background

Atorvastatin (a tor" va stat' in) is a potent, orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), atorvastatin lowers total serum cholesterol and low density lipoprotein (LDL) concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Atorvastatin was approved for use in the United States in 1996 and has become one of the most commonly prescribed drugs in America, with more than 100 million prescriptions filled yearly. The current primary indication for atorvastatin is the treatment of hypercholesterolemia in persons at high risk for coronary, cerebrovascular and peripheral artery disease. Atorvastatin is available in tablets of 10, 20, 40 and 80 mg generically and under the trade name Lipitor. It is also available in combination with other cardiovascular agents such as amlodipine (Caduet and generics) and ezetimibe (Lypqozet). The recommended dose is 10 to 80 mg once daily based upon tolerability and lipid levels. Common side effects include muscle cramps, headache, joint aches, abdominal pain, nausea, and weakness, symptoms that occur with all the currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Atorvastatin therapy is associated with mild, asymptomatic and usually transient serum aminotransferase elevations in 1% to 3% of patients but levels above 3 times ULN in less than 1%. In summary analyses of large scale studies with prospective monitoring, ALT elevations above 3 times the upper limit of normal (ULN) occurred in 0.7% of atorvastatin treated versus 0.3% of placebo recipients. These elevations were more common with higher doses of atorvastatin, being 2.3% with 80 mg daily. Most elevations were self-limited and did not require dose modification.

Atorvastatin is also associated with frank, clinically apparent hepatic injury but this is rare, occurring in approximately 1 in 10,000 treated patients. The clinical presentation of atorvastatin hepatotoxicity varies greatly from simple cholestatic hepatitis to mixed forms, to frankly hepatocellular injury. The latency to onset of injury is also highly variable ranging from 1 month to several years. However, most cases arise within 6 months of starting atorvastatin or several months after a dose escalation. The most common presentation is a cholestatic hepatitis that tends to be mild-to-moderate in severity and self-limiting in course (Cases 1 and 2). Atorvastatin hepatotoxicity can also present with a distinctly hepatocellular pattern of injury with marked elevations in serum aminotransferase levels and minimal or no increase in alkaline phosphatase. Rash, fever and eosinophilia are uncommon, but at least one-third of hepatocellular cases have features of autoimmunity, marked by high immunoglobulin levels, ANA or SMA positivity and liver biopsy findings that resemble autoimmune hepatitis (Cases 3 and 4). These autoimmune cases usually resolve once atorvastatin is stopped, although they may require corticosteroid therapy for resolution. Strikingly, however, some cases of apparent autoimmune hepatitis caused by atorvastatin do not resolve with stopping the medication but are self-sustained and require long term immunosuppressive therapy. It is unclear whether these cases of persistent autoimmune hepatitis are caused by the statin therapy or are triggered by statin in a susceptible host. Another possibility is that the association is coincidental and represents a de novo onset of autoimmune hepatitis in someone who happens to be taking a statin.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from atorvastatin is unknown. Atorvastatin is largely metabolized in the liver via CYP 3A4 and is excreted in bile. The mild, self-limited ALT elevations are likely due to a toxic intermediate of drug metabolism and the reversal of these elevations due to adaptation. The idiosyncratic, clinically apparent liver injury associated with atorvastatin has many features of autoimmunity and may be immune mediated. Other cases may be due to failure of adaptation.

Because atorvastatin is metabolized by CYP 3A4, it is susceptible to many drug-drug and even drug-food and drug-herb interactions. Strong inhibitors of CYP 3A4 such as clarithromycin, ritonavir (and other HIV protease inhibitors), itraconazole, verapamil and grapefruit juice (high consumption) can increase atorvastatin levels, and the dose should be kept to 20 mg daily or less. Cyclosporine, fibrates and niacin can increase the risk of myopathy from atorvastatin. On the other hand, rifampin and other inducers of CYP 3A4 can decrease atorvastatin levels and efficacy. Drug induced liver injury from atorvastatin has sometimes occurred after long term use of the statin, but shortly after additions or discontinuations or modifications of other medications being taken.

### Outcome and Management

The product label for atorvastatin recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The mild ALT elevations associated with atorvastatin therapy are usually self-limited and do not require dose modification. Atorvastatin should be stopped if ALT levels rise above 10-fold normal or persist in being above 5-fold elevated or are associated with symptoms of liver injury. However, prospective monitoring of serum enzymes upon initiating atorvastatin therapy is no longer recommended. Clinically apparent liver injury attributed to atorvastatin is usually self-limited and recovery is complete within 1 to 4 months. Several instances of an autoimmune chronic hepatitis have been reported after atorvastatin therapy that required long term immunosuppressive therapy despite stopping atorvastatin, suggesting that the drug triggered an underlying predisposition to autoimmune hepatitis. In other instances, the liver disease ultimately resolved with stopping atorvastatin. In addition, rare instances of acute liver failure have been attributed to atorvastatin, but in these cases the role of atorvastatin in causing the hepatic injury was not always clear. In view of the widescale use of atorvastatin, clinically apparent and severe liver injury is extraordinarily rare. Recurrence of injury with rechallenge has been reported and should be avoided. Switching therapy to another statin after atorvastatin induced injury is apparently safe, but few instances have been reported, and it should be done with careful monitoring for recurrence. In cases of autoimmune hepatitis-like injury, corticosteroids have been used but with unclear efficacy. If corticosteroids are used, the dose and duration of treatment should be kept to a minimum, and careful follow up after stopping is essential.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Ezetimibe [used in combination], Fluvastatin, Lovastatin, Pitavastatin, Pravastatin, Rosuvastatin, Simvastatin

## CASE REPORTS

### Case 1. Abnormal serum enzymes arising during atorvastatin therapy.(1)

A 71 year old woman was found to have marked elevations in serum ALT and alkaline phosphatase 6 weeks after switching from simvastatin to atorvastatin (80 mg/day) for hyperlipidemia. Her serum ALT levels had been normal on simvastatin (Table). She was asymptomatic and serum bilirubin levels were normal. She had also been taking an herbal weight loss agent which was stopped at the same time as atorvastatin. Serum enzyme levels returned to normal and remained normal during subsequent lovastatin therapy. Switching to atorvastatin again (in lower doses) was followed by a rise in ALT and alkaline phosphatase levels and appearance of pruritus within a week. She was not jaundiced, but direct bilirubin was elevated (total=1.1 and direct=0.6 mg/dL). Atorvastatin was again stopped, and serum enzymes fell into the normal range and remained normal on subsequent long term lovastatin therapy.

#### Key Points

Medication: | Atorvastatin (80 mg daily)
Pattern: | Cholestatic (R=1.1 initially; 2.0 on reexposure)
Severity: | 1+ (no jaundice)
Latency: | 6 weeks initially, <1 week on re-exposure
Recovery: | ~1 month
Other medications: | Herbal weight loss agent (first exposure only)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 12 | | | While on Simvastatin
0 | | Switched to Atorvastatin (80 mg/day)
6 weeks | 0 | 262 | | | Atorvastatin stopped
7 weeks | 6 days | 75 | 694 | 0.5 | Asymptomatic
24 weeks | 23 weeks | 15 | 135 | | On Lovastatin
| | Atorvastatin (20 mg/day) restarted
5 days | 0 | 478 | 711 | 1.1 | Atorvastatin stopped
10 days | 5 days | 108 | 404 | 0.5 | Itching
22 days | 17 days | 20 | 223
12 weeks | 11 weeks | 13 | 127 | 0.4 | On Lovastatin
Normal Values | | <42 | <117 | <1.2

#### Comment

The rapid recurrence of liver test abnormalities within days of reexposure is convincing evidence that the initial episode was due to atorvastatin (rather than the herbal weight loss agent) and that the abnormalities were not simple aminotransferase elevations that are common on statin therapy, but rather a manifestation of mild idiosyncratic liver injury with a distinctive cholestatic pattern.

### Case 2. Cholestatic hepatitis due to atorvastatin.(2)

A 72 year old man with hyperlipidemia was treated with atorvastatin (20 mg daily) which he took intermittently for 4 to 5 months. Having stopped therapy for 3 months, he restarted it at a dose of 40 mg daily, and one week later developed dark urine and jaundice. He had no constitutional symptoms of fatigue, nausea or abdominal pain and had no fever or rash. Laboratory testing revealed elevations in ALT, alkaline phosphatase and bilirubin levels (Table). He had no history of liver disease or exposures to viral hepatitis and did not drink alcohol. He took prednisone and folic acid for anemia believed to be due to myelofibrosis. Tests for hepatitis A, B and C were negative as were AMA and SMA. ANA was positive at 1:80 but was known to be elevated for several years before treatment with atorvastatin. Ultrasound of the abdomen and MRCP showed no evidence of biliary disease. A liver biopsy showed intrahepatic cholestasis and mixed inflammatory infiltrates compatible with drug induced liver injury. Stopping atorvastatin was followed by a slow return of laboratory tests to normal. His hyperlipidemia was subsequently managed with ezetimibe.

#### Key Points

Medication: | Atorvastatin (40 mg daily)
Pattern: | Mixed (R=3), later cholestatic
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 week on reexposure
Recovery: | ~3-6 months
Other medications: | Prednisone, folic acid

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 18 | 282 | 0.9
Pre | | 40 | 174 | 0.7 | Atorvastatin started
4 months | | 66 | 250 | 0.6 | Atorvastatin stopped
0 | | 49 | 205 | 0.8 | Atorvastatin restarted
8 days | 0 | 538 | 920 | 8.0 | Atorvastatin stopped
14 days | 6 days | 679 | 1259 | 7.4 | Liver biopsy
21 days | 13 days | 441 | 1141 | 3.4
35 days | 27 days | 214 | 746 | 1.6
3 months | 3 months | 72 | 431 | 1.0
9 months | 9 months | 39 | 213 | 1.0
12 months | 12 months | 35 | 213 | 1.0
Normal Values | | <55 | <270 | <1.2

#### Comment

The rapid development of a cholestatic hepatitis after reintroduction of atorvastatin suggests an immuno-allergic form of idiosyncratic drug induced liver injury. While the serum enzyme elevations qualified as being “mixed”, the clinical course was cholestatic.

### Case 3. Self-limited autoimmune hepatitis-like injury arising during atorvastatin and ezetimibe therapy.(3)

A 50 year old woman developed nausea, abdominal pain and jaundice with features of autoimmune hepatitis during combination therapy with atorvastatin (80 mg daily for 16 months) and ezetimibe (10 mg daily for 3 months). There was no previous history of liver disease, and laboratory tests had been normal shortly before ezetimibe was started. She had multiple other medical problems including coronary artery disease, osteoarthritis, hypothyroidism, and gastroesophageal reflux. She drank little alcohol and had no exposures to hepatitis. On presentation, she had epigastric tenderness but no rash or fever. Laboratory tests showed raised bilirubin and serum enzymes (Table). Both ezetimibe and atorvastatin were stopped. Tests for hepatitis A, B and C were negative and ultrasound imaging showed no evidence of biliary obstruction. A liver biopsy showed hepatitis with eosinophils and plasma cells. She tested positive for antinuclear antibody and antibodies to double-stranded DNA (anti-dsDNA). Over the next few weeks, her symptoms resolved and laboratory tests improved. Six weeks after onset, her liver tests were normal and autoantibody levels had fallen. She was started on rosuvastatin for her hypercholesterolemia and did well without recurrence of symptoms or liver test abnormalities.

#### Key Points

Medication: | Atorvastatin (80 mg daily) and ezetimibe (10 mg daily)
Pattern: | Hepatocellular (R=10.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 months for atorvastatin; 12 weeks for ezetimibe
Recovery: | ~6 weeks
Other medications: | Furosemide, diltiazem, diclofenac, acetaminophen, atenolol, ibuprofen, clopidogrel, thyroxine, lactulose, and nitrates

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 17 | 75 | 0.5 | Atorvastatin (~13 months)
0 | | Ezetimibe (10 mg/day) started
12 weeks | 0 | 1626 | 468 | 4.6 | ANA 1:160, anti-dsDNA 38
13 weeks | 10 days | 858 | 424 | 5.1 | ANA 1:80, anti-dsDNA 31
14 weeks | 2 weeks | 266 | 340 | 2.7
18 weeks | 6 weeks | 20 | 100 | 0.6 | ANA 1:40, anti-dsDNA 6
Normal Values | | <42 | <130 | <1.2

#### Comment

A well documented example of drug induced autoimmune hepatitis with resolution when the medication was stopped. Particularly convincing was the decrease in autoantibody titers with drug withdrawal. Ezetimibe was also a likely candidate to have caused the liver injury, but cases of autoimmune hepatitis-like injury from atorvastatin have been reported with latency to onset of more than a year.

### Case 4. Autoimmune hepatitis requiring long term immunosuppression arising during atorvastatin therapy.(4)

A 65 year old woman developed fatigue and jaundice 3 months after starting atorvastatin (20 mg daily) for long standing hypercholesterolemia for which she had previously been treated with pravastatin [6 months] and fluvastatin [3 years] before switching to atorvastatin. Her only other medication was doxazosin which she had taken for years for hypertension. She had no history of liver disease or exposures to viral hepatitis and did not drink alcohol. On examination, she was jaundiced and had hepatomegaly but no fever, rash or signs of chronic liver disease. Laboratory tests showed a hepatocellular pattern of serum enzyme elevations and mild hyperbilirubinemia (Table). Tests for viral hepatitis were negative, but she had hyperglobulinemia with IgG 6.6 g/dL (normal <1.7) and high titers of both ANA and SMA (>1:1280). A liver biopsy showed chronic hepatitis and lobular collapse and mild fibrosis. She was started on prednisone with improvement in blood tests, but three months later she still had ALT elevations and autoantibody titers had not declined. A repeat liver biopsy showed early cirrhosis.

#### Key Points

Medication: | Atorvastatin (20 mg daily)
Pattern: | Hepatocellular (R=7.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months
Recovery: | Incomplete
Other medications: | Doxazosin

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
12 | 0 | 510 | 481 | 3.0 | Prothrombin 17%
13 | 1 | 430 | | 2.5 | ANA >1:1280
14 | 2 | 280 | | 4.4 | First liver biopsy
15 | 3 | 220 | | 5.6
16 | 4 | 305 | | 4.3 | Prednisone (1 mg/kg/day)
18 | 6 | 210 | | 2.6
19 | 7 | 105 | | 2.4
22 | 10 | 80 | | 1.5 | ANA >1:1280
26 | 14 | 66 | 66 | 1.1 | Second liver biopsy
Normal Values | | <40 | <279 | <1.2

* Values estimated from Figure 3. Bilirubin converted from µmol to mg/dL.

#### Comment

Jaundice and features of autoimmune hepatitis arose after 3 months of atorvastatin therapy in a patient who had been treated with other statins for more than 3 years. Liver tests improved minimally with stopping atorvastatin and one month later prednisone was started, whereupon serum enzymes decreased from ~8-fold to ~twice normal. However, serum autoantibodies remained present in unchanging titers, and a repeat liver biopsy showed progression of fibrosis with nodularity and incomplete cirrhosis. In this case, atorvastatin appeared to trigger a self-sustained autoimmune hepatitis. An alternative explanation is that atorvastatin was an innocent bystander and the development of autoimmune hepatitis was coincidental and unrelated to the chronic statin therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atorvastatin – Generic, Lipitor®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=atorvastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atorvastatin | 134523-00-5 | C33-H35-F-N2-O5

## CITED REFERENCES

1 Gershovich OE, Lyman AE Jr. Liver function test abnormalities and pruritus in a patient treated with atorvastatin: case report and review of the literature. Pharmacotherapy. 2004;24(1):150-4.14740794
2 de Castro ML, Hermo JA, Baz A, de Luaces C, Pérez R, Clofent J. Hepatitis colestásica aguda tras la reintroducción de atorvastatina [Acute cholestatic hepatitis after atorvastatin reintroduction]. Gastroenterol Hepatol. 2006;29(1):21-4. Spanish. 16393626
3 van Heyningen C. Drug-induced acute autoimmune hepatitis during combination therapy with atorvastatin and ezetimibe. Ann Clin Biochem 2005; 42: 402-4.16168199
4 Pelli N, Setti M, Ceppa P, Toncini C, Indiveri F. Autoimmune hepatitis revealed by atorvastatin. Eur J Gastroenterol Hepatol 2003; 15: 921-4.12867804

## ANNOTATED BIBLIOGRAPHY

References updated: 3 March 2025

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; the statins have dose related hepatic effects in guinea pigs and rabbits and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; asymptomatic elevations in aminotransferases are common in patients receiving statins, but clinically significant hepatotoxicity is rare).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Dart A, Jerums G, Nicholson G, d'Emden M, Hamilton-Craig I, Tallis G, Best J, et al. A multicenter, double-blind, one-year study comparing safety and efficacy of atorvastatin versus simvastatin in patients with hypercholesterolemia. Am J Cardiol 1997; 80: 39-44. (In a study comparing atorvastatin [10 to 20 mg] to simvastatin [10 to 20 mg] for 1 year in 177 patients with hypercholesterolemia, there were "no clinically important elevations in ALT, AST or CPK" during treatment with either statin). 9205017
Black DM, Bekker-Arkema RG, Nawrocki JW. An overview of the clinical safety profile of atorvastatin (Lipitor), a new HMG-CoA reductase inhibitor. Arch Intern Med 1998; 158: 577-84. (Pooled data of 4271 patients followed for 1845 patient years in 21 clinical trials receiving atorvastatin indicated that 0.7% had ALT elevations >3 times ULN, usually within first 16 weeks, 1 patient had cholestatic hepatitis after 36 weeks, resolving in 14 weeks; dose relationship of rate of ALT elevations; 0.2% with 10 and 20 mg, 0.6% with 40 and 2.3% with 80 mg daily). 9521221
Jiménez-Alonso J, Osorio JM, Gutiérrez-Cabello F, López de la Osa A, León L, Mediavilla García JD. Atorvastatin-induced cholestatic hepatitis in a young woman with systemic lupus erythematosus. Arch Intern Med 1999; 159: 1811-2. (20 year old woman with lupus and complex medical history developed jaundice 2 months after starting atorvastatin despite concurrent prednisone therapy [bilirubin 8.2 mg/dL, ALT 783 U/L, Alk P 669 U/L], resolving within a month of stopping atorvastatin). 10448788
Nakad A, Bataille L, Hamoir V, Sempoux C, Horsman Y. Atorvastatin-induced hepatitis with the absence of cross-toxicity with simvastatin. Lancet 1999; 353: 1763-4. (70 year old woman developed nausea and weakness after 12 weeks of atorvastatin therapy [bilirubin not given, ALT 230 U/L, Alk P 591 U/L], returning to normal 2 weeks after stopping and no recurrence with simvastatin). 10347994
Wierzbicki AS, Crook MA. Cholestatic liver dysfunction. Lancet 1999; 354: 954. (Among 275 patients with familial hyperlipidemia, 3% had ALT elevations and 2 had raised alkaline phosphatase and slight bilirubin elevations during atorvastatin therapy; resolving after switching to fluvastatin). 10489985
Sreenarasimhaiah J, Shiels P, Lisker-Melman M. Multiorgan failure induced by atorvastatin. Am J Med 2002; 113: 348-9. (65 year old woman developed jaundice on atorvastatin, resolving when stopping, but recurring in severe form with restarting [bilirubin 25 mg/dL, ALT 290 U/L], progressing to liver and renal failure, myocardial infarction, pancreatitis and death). 12361829
Lewin JJ 3rd, Nappi JM, Taylor MH. Rhabdomyolysis with concurrent atorvastatin and diltiazem. Ann Pharmacother 2002; 36: 1546-9. (60 year old man on long term atorvastatin developed rhabdomyolysis 3 weeks after starting diltiazem [bilirubin 0.7 mg/dL, ALT 1610 U/L, Alk P 287 U/L, CPK 1898 U/L and myoglobinemia], resolving rapidly with stopping medications). 12243603
Gagné C, Gaudet D, Bruckert E; Ezetimibe Study Group. Efficacy and safety of ezetimibe coadministered with atorvastatin or simvastatin in patients with homozygous familial hypercholesterolemia. Circulation 2002; 105: 2469-75. (Prospective trial comparing the combination of ezetimibe and either atorvastatin or simvastatin to the statin alone in 50 patients with homozygous familial hypercholesterolemia; side effects were similar; two patients on combination therapy had ALT elevations >3 times ULN, but both resolved without stopping therapy). 12034651
Ridruejo E, Mando OG. Acute cholestatic hepatitis after reinitiating treatment with atorvastatin. J Hepatol 2002; 37: 165-6. (69 year old man developed jaundice 7 months after starting atorvastatin [bilirubin 2.6 mg/dL, ALT 72 U/L, Alk P 3767 U/L, eosinophilia, ANA negative], resolving within 4 months of stopping; he was previously treated with simvastatin and pravastatin without problems). 12076881
Kiortsis DN, Nikas S, Hatzidimou K, Tsianos E, Elisaf MS. Lipid-lowering drugs and serum liver enzymes: the effects of body weight and baseline enzyme levels. Fundam Clin Pharmacol 2003; 17: 491-4. (Among 163 patients treated with various lipid lowering drugs, proportion with elevated ALT levels was 9.1% before treatment, 9.5% at 8 weeks and 9.1% at 24 weeks; similar at all body weights, but ALT elevations more frequent in obese and overweight subjects). 12914553
Graziadei IW, Obermoser GE, Sepp NT, Erhart KH, Vogel W. Drug-induced lupus-like syndrome associated with severe autoimmune hepatitis. Lupus 2003; 12: 409-12. (58 year old woman developed abdominal pain after 7 months of atorvastatin with biopsy findings of autoimmune hepatitis, ANA 1:640 and skin rash [lupus], responding poorly to corticosteroids [bilirubin 4.5 mg/dL, ALT 263 U/L, Alk P 270 U/L, IgG 2.7 gm/dL], ultimately requiring long term tacrolimus and mycophenolate for control). 12765306
Pelli N, Setti M, Ceppa P, Toncini C, Indiveri F. Autoimmune hepatitis revealed by atorvastatin. Eur J Gastroenterol Hepatol 2003; 15: 921-4. (65 year old woman developed jaundice 3 months after starting atorvastatin [bilirubin 3.0 mg/dL, ALT 510 U/L, Alk P 481 U/L, IgG 6.58 gm/dL, both ANA and SMA >1:1280]; only partial response to prednisone with evolution to cirrhosis and requiring long term corticosteroid therapy: Case 4). 12867804
Perger L, Kohler M, Fattinger K, Flury R, Meier PJ, Pauli-Magnus C. Fatal liver failure with atorvastatin. J Hepatol 2003; 39: 1095-7. (85 year old man developed jaundice 2 weeks after starting atorvastatin 20 mg daily [bilirubin 25 mg/dL, ALT 1401 U/L, Alk P 393 U/L], worsened despite stopping drug with subsequent coma, hepato-renal syndrome and death). 14642636
Pelli N, Setti M. Atorvastatin as a trigger of autoimmune hepatitis. J Hepatol 2004; 40: 716. (Letter in response to Perger [2003], summarizing their previously published case, Pelli [2003]). 15030994
Parra JL, Reddy KR. Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis 2003; 7: 415-33. (Review and discussion of individual hypolipidemic agents: atorvastatin is associated with ALT elevations >3 times ULN in 0.7%, but only 0.3% stopped therapy because of these abnormalities). 12879992
Bays HE, Dujovne CA, McGovern ME, White TE, Kashyap ML, Hutcheson AG, Crouse JR; Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation. Comparison of once-daily, niacin extended-release/lovastatin with standard doses of atorvastatin and simvastatin(the Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation [ADVOCATE]). Am J Cardiol 2003; 91: 667-72. (Controlled trial comparing lovastatin combined with niacin to atorvastatin or simvastatin alone in 315 patients for 16 weeks; no patient had confirmed ALT elevation >3 times ULN). 12633795
Newman CB, Palmer G, Silbershatz H, Szarek M. Safety of atorvastatin derived from analysis of 44 completed trials in 9,416 patients. Am J Cardiol 2003; 92: 670-76. (Pooled data from 44 trials which included 9,416 patients treated with atorvastatin; ALT was >3 times ULN in 0.5% of atorvastatin vs 0.3% of placebo recipients; rates rising from 0.13% with 10 and 20 mg, 0.4% with 40 mg, and 0.9% with 80 mg of atorvastatin daily). 12972104
Jacobson TA. Comparative pharmacokinetic interaction profiles of pravastatin, simvastatin, and atorvastatin when coadministered with cytochrome P450 inhibitors. Am J Cardiol 2004; 94: 1140-6. (Pharmacokinetic studies showing that drugs that inhibit CYP 3A4, the major P450 drug metabolizing enzyme, [itraconazole, clarithromycin, verapamil] cause increases in blood levels of simvastatin and atorvastatin but have little effect on pravastatin levels). 15518608
Gershovich OE, Lyman AE Jr. Liver function test abnormalities and pruritus in a patient treated with atorvastatin: case report and review of the literature. Pharmacotherapy 2004; 24: 150-4. (71 year old woman developed ALT and Alk P elevations after taking atorvastatin for 2 months, which resolved rapidly but recurred after 4 days of restarting drug with itching [bilirubin 1.1 mg/dL, ALT 478 U/L, Alk P 711 U/L], resolving rapidly with stopping and not recurring on switching to lovastatin: Case 1). 14740794
Geoghegan M, Smith V, Green JRB. Acute cholestatic hepatitis associated with atorvastatin. Gut 2004; 53: A123. [Abstract] (Two patients, 1 woman and 1 man, ages 57 and 63 years, developed jaundice 4 and 12 weeks after starting atorvastatin [bilirubin 34.3 and 1.1 mg/dL, ALT 931 and 283 U/L, Alk P 156 and 216 U/L, ANA negative], resolving 8 weeks after stopping).
Chalasani N, Aljadhey H, Kesterson J, Murray MD, Hall SD. Patients with elevated liver enzymes are not at higher risk for statin hepatotoxicity. Gastroenterology 2004; 126: 1287-92. (Retrospective analysis of electronic records found similar rates of severe ALT or AST elevations with or without statin [atorvastatin, simvastatin or fluvastatin] therapy [0.6% vs 0.4%] in those with baseline elevations). 15131789
Kaplowitz N. Statin-induced hepatotoxicity. Gastroenterology 2004; 127: 1278. (Letter in response to Chalasani [2004] requesting additional information on cohorts: reply by authors provides what was available). 15481021
de Denus S, Spinler SA, Miller K, Peterson AM. Statins and liver toxicity: a meta-analysis. Pharmacotherapy 2004; 24: 584-91. (In 13 controlled trials with 49,275 patients with routine liver test monitoring for an average of 3.6 years, statin therapy was not associated with increased rate of liver test abnormalities [1.14% vs 1.05%: odds ratio=1.26; 95% CI=0.99-1.62] compared to placebo). 15162892
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to statins including simvastatin in 1 and cerivastatin in 2). 15390328
Alsheikh-Ali AA, Karas RH. Adverse events with concomitant amiodarone and statin therapy. Prev Cardiol 2005; 8: 95-7. (Review of MedWatch adverse event reports for proportion of cases attributed to different statins that included combination with amiodarone; 1.0% for simvastatin, 0.7% atorvastatin, and 0.4% pravastatin; 77% muscle, 30% liver involvement). 15860984
Nissen SE. Effect of intensive lipid lowering on progression of coronary atherosclerosis: evidence for an early benefit from the Reversal of Atherosclerosis with Aggressive Lipid Lowering (REVERSAL) trial. Am J Cardiol 2005; 96 (5A): 61F-68F. (Controlled trial comparing pravastatin [40 mg] to atorvastatin [80 mg] daily for 18 months in 654 patients; ALT elevations >3 times ULN occurred in 1.6% on pravastatin vs 2.3% on atorvastatin, but no instances of clinically apparent hepatitis). 15979434
van Heyningen C. Drug-induced acute autoimmune hepatitis during combination therapy with atorvastatin and ezetimibe. Ann Clin Biochem 2005; 42: 402-4. (50 year old woman developed jaundice 16 months after starting atorvastatin and 3 months after starting ezetimibe [bilirubin 4.6 mg/dL, AST 1626 U/L, Alk P 468 U/L, positive ANA and anti-dsDNA], resolving 6 weeks after stopping both: Case 3). 16168199
Charles EC, Olson KL, Sandhoff BG, McClure DL, Merenich JA. Evaluation of cases of severe statin-induced transaminitis within a large health maintenance organization. Am J Med 2005; 118: 618-24. (Among 23,000 patients on statins in a health plan, 17 had an ALT elevation >10 times ULN attributable to statin use; 10 on simvastatin, 5 lovastatin, and 2 atorvastatin; onset 2 days to 4 years after starting; 10 symptomatic; all resolved within 2-8 weeks, except one death; 3 of 7 recurred on rechallenge, 5 of 6 tolerated switching to another statin; two atorvastatin cases had ALT 1481 and 478 U/L, bilirubin 1.3 and 1.1 mg/dL, resolved in 5 and 2 weeks). 15922693
Alsheikh-Ali AA, Ambrose MS, Kuvin JT, Karas RH. The safety of rosuvastatin as used in common clinical practice: a postmarketing analysis. Circulation 2005; 111: 3051-7. (Review of adverse event reporting for rosuvastatin during first year of marketing; liver related events rates were higher for rosuvastatin [~25/million prescriptions] than other statins [~4/million] and higher for comparable periods for simvastatin, pravastatin and atorvastatin). 15911706
Ballantyne CM, Abate N, Yuan Z, King TR, Palmisano J. Dose-comparison study of the combination of ezetimibe and simvastatin (Vytorin) versus atorvastatin in patients with hypercholesterolemia: the Vytorin Versus Atorvastatin (VYVA) study. Am Heart J 2005; 149: 464-73. (Controlled trial of ezetimibe/simvastatin vs atorvastatin in 1902 patients with hypercholesterolemia, ALT elevations >3 times ULN occurred in 1.1% on atorvastatin and none on ezetimibe/simvastatin). 15864235
LaRosa JC, Grundy SM, Waters DD, Shear C, Barter P, Fruchart JC, Gotto AM, et al.; Treating to New Targets (TNT) Investigators. Intensive lipid lowering with atorvastatin in patients with stable coronary disease. N Engl J Med 2005; 352: 1425-35. (Controlled trial of 10 mg or 80 mg of atorvastatin daily in 10,001 patients with coronary artery disease and LDL cholesterol of <130 mg/dL for an average of 4.9 years; rate of confirmed ALT elevation >3 times ULN 1.2% with high dose and 0.2% with low dose atorvastatin; 5 cases of rhabdomyolysis, but no hepatitis reported). 15755765
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Analysis of 461 cases of drug induced liver disease diagnosed between 1994 to 2004 in Spanish Registry; 11 cases were attributed to "statins", but no specific agent caused more than 4 cases). 16083708
Andrade RJ, Lucena MI, Kaplowitz N, García-Munoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (28 of 493 [5.7%] cases of drug induced liver disease were found to have evidence of chronic injury, including 2 cases due to atorvastatin with raised serum enzymes 9 and 17 months after an acute anicteric liver injury). 17133470
Clarke AT, Mills PR. Atorvastatin associated liver disease. Dig Liver Dis 2006; 38: 772-7. (7 cases of atorvastatin liver injury from 1 center between 2002-5; ages 50 to 78 years, arising 3-52 weeks after starting [bilirubin levels ranging from 0.6 to 40.2 mg/dL, AST 76 to 1702 U/L, Alk P 410 to 1935 U/L], resolving within 1-10 months of stopping, 1 death and 1 prolonged). 16777499
Khorashadi S, Hasson NK, Cheung RC. Incidence of statin hepatotoxicity in patients with hepatitis C. Clin Gastroenterol Hepatol 2006; 4: 902-7. (Electronic record review of rate of ALT elevations in patients with hepatitis C with or without statin therapy and controls on statin therapy found no differences between the three groups [20%, 24% and 17%]; severe abnormalities most frequent in patients with chronic hepatitis C not on statins [6.6% vs 1.2%]). 16697272
Cohen DE, Anania FA, Chalasani N, National Lipid Association Statin Safety Task Force Liver Expert Panel. An assessment of statin safety by hepatologists. Am J Cardiol 2006; 97 (8A): 77C-81C. (Expert opinion of panel of academic hepatologists; statins as a class are associated with low rates of moderate ALT elevations during therapy, particularly with higher doses, but these are generally not indicative of significant liver injury, acute liver failure being very rare; routine monitoring of serum aminotransferase levels is not necessary; statins can be used safely in patients with chronic liver disease including nonalcoholic fatty liver). 16377288
Conforti A, Magro L, Moretti U, Scotto S, Motola D, Salvo F, Ros B, et al. Fluvastatin and hepatic reactions: a signal from spontaneous reporting in Italy. Drug Safety 2006; 29:1163-72. (Italian Pharmacovigilance Group review of 35,757 adverse reaction reports; 1260 due to statins of which 178 were hepatic: 69 [36%] fluvastatin, 37 [21%] atorvastatin, 50 [28%] simvastatin, 16 [9%] pravastatin, 6 [3%] rosuvastatin; proportion reporting rate based on number of prescriptions was highest for fluvastatin [~9] compared to other agents [~2-3]; 26 fluvastatin cases described as “hepatitis”, but no details given except that most cases occurred within 90 days of starting). 17147462
Law M, Rudnicka AR. Statin safety: a systematic review. Am J Cardiol 2006; 97(8A): 52C-60C. (Review of safety of statins; 38 cases of acute liver failure submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations >3 times ULN is 0.1% with statins and 0.04% with placebo). 16581329
Goldberg RB, Guyton JR, Mazzone T, Weinstock RS, Polis A, Edwards P, Tomassini JE, et al. Ezetimibe/simvastatin vs atorvastatin in patients with type 2 diabetes mellitus and hypercholesterolemia: the VYTAL study. Mayo Clin Proc 2006; 81: 1579-88. (Controlled trial of atorvastatin vs simvastatin/ezetimibe in 1229 patients with diabetes and hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.3% of atorvastatin vs no simvastatin/ezetimibe treated patient, and no clinically apparent liver injury). 17165637
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of drug induced liver fatality; none of the statins were in the top 20 suspected causes). 16054882
Alla V, Abraham J, Siddiqui J, Raina D, Wu GY, Chalasani NP, Bonkovsky HL. Autoimmune hepatitis triggered by statins. J Clin Gastroenterol 2006; 40: 757-61. (Three cases of autoimmune hepatitis arising after simvastatin or atorvastatin therapy 6, 20 and 20 weeks after starting [bilirubin 11.3, 3.4 and 5.5 mg/dL, ALT 1749, 1170 and 155 U/L, Alk P of 228, 160, and 203 U/L, all being ANA or SMA positive in titers of 1:40 to 1:160], all responding to prednisone/azathioprine, but remaining on long term therapy with azathioprine or mycophenolate alone). 16940892
de Castro ML, Hermo JA, Baz A, de Luaces C, Perez R, Clofent J. [Acute cholestatic hepatitis after atorvastatin reintroduction]. Gastroenterol Hepatol 2006; 29: 21-4. Spanish. (72 year old man developed jaundice one week after restarting atorvastatin therapy [bilirubin 8.0 mg/dL, ALT 538 U/L, Alk P 1259 U/L], resolving slowly with stopping therapy: Case 2). 16393626
Clearfield MB, Amerena J, Bassand JP, Hernández García HR, Miller SS, Sosef FF, Palmer MK, et al. Comparison of the efficacy and safety of rosuvastatin 10 mg and atorvastatin 20 mg in high-risk patients with hypercholesterolemia – Prospective study to evaluate the Use of Low doses of the Statins Atorvastatin and Rosuvastatin (PULSAR). Trials 2006; 7: 35. (Controlled trial comparing rosuvastatin [10 mg] vs atorvastatin [20 mg] daily for 6 weeks; one patient on atorvastatin had confirmed ALT elevations >3 times ULN; no clinically apparent liver injury). 17184550
Amarenco P, Bogousslavsky J, Callahan A 3rd, Goldstein LB, Hennerici M, Rudolph AE, Sillesen H, et al.; Stroke Prevention by Aggressive Reduction in Cholesterol Levels (SPARCL) Investigators. High-dose atorvastatin after stroke or transient ischemic attack. N Engl J Med 2006; 355: 549-59. (Controlled trial of atorvastatin [80 mg] vs placebo for 4-6 years in 4731 patients with cerebrovascular disease and hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 2.2% of atorvastatin vs 0.5% of placebo recipients; no cases of liver failure). 16899775
Gómez-Domínguez E, Gisbert JP, Moreno-Monteagudo JA, García-Buey L, Moreno-Otero R. A pilot study of atorvastatin treatment in dyslipidemia, non-alcoholic fatty liver patients. Aliment Pharmacol Ther 2006; 23: 1643-7. (Open label study of a one year course of atorvastatin in various doses for nonalcoholic liver disease found some degree of improvement in ALT, AST and GGT levels). 16696815
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. Statin-related adverse events: a meta-analysis. Clin Ther 2006; 28: 26-35. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations >3 times ULN in 1.7% of statin vs 1.4% placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin). 16490577
Arca M. Atorvastatin: a safety and tolerability profile. Drugs 2007; 67 Suppl 1: 63-9. (Review of safety of atorvastatin; ALT elevations >3 times ULN occur in <1% of statin recipients, but rate may be higher with higher doses of atorvastatin, estimate of rate of acute liver failure is ~1 per million persons years). 17910522
Bhardwaj SS, Chalasani N. Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 597-613. (Review of hepatotoxicity of statins; reported rates of ALT or AST elevations >3 times ULN; atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0%, and simvastatin 1.8%; usually asymptomatic, individual case reports of autoimmune hepatitis). 17723922
Alsheikh-Ali AA, Maddukuri PV, Han H, Karas RH. Effect of the magnitude of lipid lowering on risk of elevated liver enzymes, rhabdomyolysis, and cancer: insights from large randomized statin trials. J Am Coll Cardiol 2007; 50: 409-18. (Systematic review of relationship between LDL cholesterol lowering effects and adverse events in 23 statin treatment arms representing 309,506 person years of therapy; positive and graded relationship between statin dose [simvastatin, lovastatin and atorvastatin] and rates of ALT elevations, but no independent relationship to degree of LDL cholesterol decrease). 17662392
Dale KM, White CM, Henyan NN, Kluger J, Coleman CI. Impact of statin dosing intensity on transaminase and creatine kinase. Am J Med 2007; 120: 706-12. (Metaanalysis of rates of ALT and CPK elevations in nine controlled studies comparing low vs high doses of statins; ALT elevations >3 times ULN occurred in 1.5% of high- and 0.4% of low-intensity statin groups, effect particularly seen with hydrophilic [pravastatin and atorvastatin] compared to lipophilic agents [simvastatin and lovastatin]). 17679130
Silva M, Matthews ML, Jarvis C, Nolan NM, Belliveau P, Malloy M, Gandhi P. Meta-analysis of drug-induced adverse events associated with intensive-dose statin therapy. Clin Ther 2007; 29: 253-60. (Metaanalysis of rates of adverse events in 4 controlled trials in 108,049 patient years comparing standard to intensive-dose statin therapy; increased risk of ALT elevations >3 times ULN with intensive therapy [odds ratio 4.5; absolute risk 1.2%], but no mention of clinically apparent liver injury). 17472818
Alsheikh-Ali AA, Karas RH. Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone (from the United States Food and Drug Administration Adverse Event Reporting System). Am J Cardiol 2007; 99: 379-81. (Analysis of MedWatch reports of adverse events found no excess in liver related adverse event reports per million prescriptions due to lovastatin alone [2.3] vs niacin alone [2.5] vs the combination [3.2], but slightly higher rates with atorvastatin [4.5], simvastatin [5.7] and pravastatin [4.9], but data relied upon spontaneous reporting). 17261402
Segarra-Newnham M, Parra D, Martin-Cooper EM. Effectiveness and hepatotoxicity of statins in men seropositive for hepatitis C virus. Pharmacotherapy 2007; 27: 845-51. (Retrospective analysis of electronic records on 146 men with chronic hepatitis C who started statin therapy [simvastatin mostly, but also fluvastatin, lovastatin, pravastatin, and atorvastatin, <4 each], mean ALT levels did not change and percent with ALT >3 times ULN was 8% at baseline, 10% at 3 months, 11% at 6 months and 8% at 22 months; only one patient stopped therapy for ALT elevations). 17542767
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, no cases were attributed to statins). 17539979
Leiter LA, Bays H, Conard S, Bird S, Rubino J, Hanson ME, Tomassini JE, et al. Efficacy and safety of ezetimibe added on to atorvastatin (40 mg) compared with uptitration of atorvastatin (to 80 mg) in hypercholesterolemic patients at high risk of coronary heart disease. Am J Cardiol 2008; 102: 1495-501. (Controlled trial of adding ezetimibe vs increasing atorvastatin dosage in 579 patients; ALT or AST elevations >3 times the ULN occurred in 1 patient in both groups). 19026303
Escobar C, Echarri R, Barrios V. Relative safety profiles of high dose statin regimens. Vasc Health Risk Manag 2008; 4: 525-33. (Review of efficacy and safety of use of higher doses of statins to achieve lower LDL cholesterol levels; ALT elevations are more frequent [2-3%] with higher than lower [~1%] doses). 18827903
Hyogo H, Tazuma S, Arihiro K, Iwamoto K, Nabeshima Y, Inoue M, Ishitobi T, et al. Efficacy of atorvastatin for the treatment of nonalcoholic steatohepatitis with dyslipidemia. Metabolism 2008; 57: 1711-8. (Open label trial of 24 month course of atorvastatin [10 mg daily] in 31 patients with nonalcoholic steatohepatitis; improvements in serum ALT levels [mean 98 to 36 U/L], cholesterol and triglyceride levels and steatosis, but apparent worsening of fibrosis in some patients; no hepatotoxicity). 19013295
Rahier JF, Rahier J, Leclercq I, Geubel AP. Severe acute cholestatic hepatitis with prolonged cholestasis and bile-duct injury following atorvastatin therapy: a case report. Acta Gastroenterol Belg 2008; 71: 318-20. (52 year old developed severe liver injury 5 weeks after starting atorvastatin, 10 mg daily [bilirubin 5.9 rising to ~29 mg/dL, ALT 6838 U/L, Alk P ~150 U/L, ANA negative, INR 1.9], severe itching and slow recovery requiring 6 months for normalization of bilirubin). 19198578
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected from 2004 to 2008 in the US, 9 [3%] were attributed to statins, including 3 to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin, but most cases were mild and some were not clearly attributable to the statin therapy). 18955056
Martin JE, Cavanaugh TM, Trumbull L, Bass M, Weber F Jr, Aranda-Michel J, Hanaway M, et al. Incidence of adverse events with HMG-CoA reductase inhibitors in liver transplant patients. Clin Transplant 2008; 22: 113-9. (Retrospective review of adverse events associated with statin and fibrate use in 69 patients with liver transplants; myalgias problematic in 5, myopathy in 1, but none had significant ALT elevations or hepatitis related to medication). 18217912
Robinson JG, Ballantyne CM, Grundy SM, Hsueh WA, Parving HH, Rosen JB, Adewale AJ, et al. Lipid-altering efficacy and safety of ezetimibe/simvastatin versus atorvastatin in patients with hypercholesterolemia and the metabolic syndrome(from the VYMET study). Am J Cardiol 2009; 103: 1694-702. (Controlled trial of ezetimibe/simvastatin versus atorvastatin alone in 1128 patients with metabolic syndrome and hypercholesterolemia; adverse event rates were similar in the two groups, but confirmed ALT or AST elevations >3 times ULN occurred in 0.3% of atorvastatin vs 1.4% of ezetimibe/simvastatin treated patients). 19539078
Koren MJ, Feldman T, Mendes RA. Impact of high-dose atorvastatin in coronary heart disease patients age 65 to 78 years. Clin Cardiol 2009; 32: 256-63. (Controlled trial of high [up to 80 mg daily] vs standard dose [10 mg] atorvastatin in 2442 patients, analysis of subgroup of 1001 who were 65 to 78 years of age; ALT elevations >3 times ULN occurred in 1.3% in younger vs 14% in older cohort receiving high dose atorvastatin; no mention of clinically apparent liver disease). 19452483
Minha S, Golzman G, Adar I, Rapoport M. Cholestatic jaundice induced by atorvastatin: a possible association with antimitochondrial antibodies. Isr Med Assoc J 2009; 11: 440-1. (68 year old man developed fever, rash and jaundice while taking atorvastatin for unknown duration [bilirubin 7.4 mg/dL, ALT 250 U/L, Alk P 555 U/L, ANA and AMA positive], recovering upon stopping but recurring three times after restarting atorvastatin, eventually resolving completely on stopping permanently). 19911499
Russo MW, Scobey M, Bonkovsky HL. Drug-induced liver injury associated with statins. Semin Liver Dis 2009; 29: 412-22. (Review of statin hepatotoxicity and the several forms of liver injury that can occur with atorvastatin, including silent aminotransferase elevations, cholestatic and hepatocellular hepatitis and an autoimmune hepatitis-like syndrome, all of which are rare; two case reports, one with an autoimmune hepatitis [bilirubin 1.0 rising to 12.5, ALT 1750 U/L, Alk P 285 U/L, ANA 1:160] responding to prednisone and one with an acute hepatitis-like onset, but subsequent cholestatic hepatitis [bilirubin 7.8 rising to 30 mg/dL, ALT 6200 U/L, Alk P 280 U/L, ANA negative], with slow but ultimately complete recovery). 19826975
Athyros VG, Tziomalos K, Gossios TD, Griva T, Anagnostis P, Kargiotis K, Pagourelias ED, et al.; GREACE Study Collaborative Group. Safety and efficacy of long-term statin treatment for cardiovascular events in patients with coronary heart disease and abnormal liver tests in the Greek Atorvastatin and Coronary Heart Disease Evaluation (GREACE) Study: a post-hoc analysis. Lancet 2010; 376 (9756): 1916-22. (Among 1600 patients with coronary artery disease treated with statins or standard therapy, mean ALT levels decreased in statin treated patients [57 to 37 U/L], but not in controls [56 to 63 U/L]; 7 of 880 statin treated patients stopped therapy because of ALT elevations, but none developed clinically apparent liver injury). 21109302
Liu Y, Cheng Z, Ding L, Fang F, Cheng KA, Fang Q, Shi GP. Atorvastatin-induced acute elevation of hepatic enzymes and the absence of cross-toxicity of pravastatin. Int J Clin Pharmacol Ther 2010; 48: 798-802. (Two men, ages 58 and 53 years, developed ALT elevations within 3 days of starting atorvastatin [peak ALT 120 and 278 U/L], resolving on stopping and not recurring on starting pravastatin). 21084035
Athyros VG, Tziomalos K, Karagiannis A, Mikhailidis DP. Atorvastatin: safety and tolerability. Expert Opin Drug Saf 2010; 9: 667-74. (Review of safety of atorvastatin concluded that liver toxicity is rare). 20553090
Hippisley-Cox J, Coupland C. Unintended effects of statins in men and women in England and Wales: population based cohort study using the QResearch database. BMJ 2010; 340: c2197. (Among 225,992 new users of statins in a UK health database, there was an increased relative risk of "moderate or serious liver dysfunction" [ALT >3 times ULN] in the range of 1.4- to 2.0-fold compared to nonusers, being higher with higher doses and during the first year of treatment; rates were highest for fluvastatin and lowest for pravastatin; rates for atorvastatin were 0.15%-0.17% per person year). 20488911
Merli M, Bragazzi MC, Giubilo F, Callea F, Attili AF, Alvaro D. Atorvastatin-induced prolonged cholestasis with bile duct damage. Clin Drug Investig 2010; 30: 205-9. (72 year old man developed jaundice 6 weeks after starting atorvastatin [bilirubin 22 mg/dL, ALT 81 U/L, Alk P 816 U/L, ANA negative], ALT elevations resolving in 5 and Alk P in 8 months). 20155993
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, 5 [2%] were attributed to atorvastatin, but no other statin listed]. 20648003
Idilman R, Bektas M, Cinar K, Toruner M, Cerit ET, Doganay B, Erden E, et al. The characteristics and clinical outcome of drug-induced liver injury: a single-center experience. J Clin Gastroenterol 2010; 44: e128-32. (Among 170 patients with drug induced liver injury seen at a single referral center in Turkey between 2001 and 2007, 14 were attributed to statins which were hepatocellular in 10 and cholestatic in 4; no details provided). 20551776
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 6 [4.5%] were attributed to statins: 2 atorvastatin, 2 simvastatin [one with ezetimibe] and 2 cerivastatin). 20949552
Conard S, Bays H, Leiter LA, Bird S, Lin J, Hanson ME, Shah A, Tershakovec AM. Ezetimibe added to atorvastatin compared with doubling the atorvastatin dose in patients at high risk for coronary heart disease with diabetes mellitus, metabolic syndrome or neither. Diabetes Obes Metab 2010; 12: 210-8. (Randomized trial comparing addition of ezetimibe to atorvastatin versus doubling the dose [40 to 80 mg daily] in 556 patients; only 1 patient in each group had ALT or AST elevations >3 times ULN during a 6 week period). 20151997
Saku K, Zhang B, Noda K; The PATROL Trial Investigators. Randomized head-to-head comparison of pitavastatin, atorvastatin, and rosuvastatin for safety and efficacy (quantity and quality of LDL). Nihon Naika Gakkai Zasshi. 201;100(12):3679-86. (Among 298 patients treated with one of three statins for 16 weeks, ALT elevations occurred in 5% on atorvastatin, 1% on rosuvastatin, and 4% of pitavastatin, but overall the three agents had similar efficacy and similar rates of toxicity).
Foster T, Budoff MJ, Saab S, Ahmadi N, Gordon C, Guerci AD. Atorvastatin and antioxidants for the treatment of nonalcoholic fatty liver disease: the St Francis Heart Study randomized clinical trial. Am J Gastroenterol 2011; 106: 71-7. (Among 1005 patients given atorvastatin with vitamin C and E for up to 4 years, 3 patients had ALT elevations >2 times ULN, but therapy appeared to decrease intrahepatic fat as assessed by CT scans). 20842109
Mackay JW, Fenech ME, Myint KS. Acute rhabdomyolysis caused by combination therapy with atorvastatin and warfarin. Br J Hosp Med (Lond). 2012;73(2):106-7. (69 year old man on long term atorvastatin therapy developed rhabdomyolysis and marked rise in INR after starting warfarin, suggesting a drug-drug interaction). 22504754
Jackevicius CA, Chou MM, Ross JS, Shah ND, Krumholz HM. Generic atorvastatin and health care costs. N Engl J Med 2012; 366: 201-4. (Atorvastatin became available generically in 2011 which may result in considerable health care savings). 22149736
Bergmann OM, Kristjansson G, Jonasson JG, Björnsson ES. Jaundice due to suspected statin hepatotoxicity: a case series. Dig Dis Sci 2012; 57: 1959-64. (3 women and 1 man, ages 55 to 85 years, developed jaundice 3, 3, 11 and 30 months after starting atorvastatin [n=3] or simvastatin [n=1], with hepatocellular or mixed injury [peak bilirubin 4.0-7.4 mg/dL, ALT 446-2987 U/L, Alk P 174-716 U/L, ANA positive in 1], all resolving spontaneously in 1-3 months). 22075853
Björnsson E, Jacobsen EI, Kalaitzakis E. Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol 2012; 56:374-80. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated: 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30-248 days; atorvastatin injury was more likely to be cholestatic and was estimated to occur in 2.9 per 100,000 person years). 21889469
Han KH, Rha SW, Kang HJ, Bae JW, Choi BJ, Choi SY, Gwon HC, et al. Evaluation of short-term safety and efficacy of HMG-CoA reductase inhibitors in hypercholesterolemic patients with elevated serum alanine transaminase concentrations: PITCH study (PITavastatin versus atorvastatin to evaluate the effect on patients with hypercholesterolemia and mild to moderate hepatic damage). J Clin Lipidol 2012; 6: 340-51. (Among 189 patients with hypercholesterolemia and ALT elevations [50-100 U/L] treated with pitavastatin vs atorvastatin for 12 weeks, there were minor ALT decreases in both groups; no placebo arm was included). 22836071
Berkelhammer C, Lerma EV. Statin treatment in patients with elevated liver enzymes: pitch to proceed. J Clin Lipidol 2012; 6: 310-1. (Editorial regarding Han [2012] stressing that chronic but stable ALT elevations are not a contraindication to use of statins). 22836066
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 7 [1.2%] attributed to statins). 22379337
Scarpini F, Cappellone R, Auteri A, Puccetti L. Role of genetic factors in statins side-effects. Cardiovasc Hematol Disord Drug Targets 2012; 12: 35-43. (Genetic variants in several genes appear to affect the frequency of side effects of statins, but to varying degrees with various statins and with different side effects). 22524173
DeGorter MK, Tirona RG, Schwarz UI, Choi YH, Dresser GK, Suskin N, Myers K, et al. Clinical and pharmacogenetic predictors of circulating atorvastatin and rosuvastatin concentrations in routine clinical care. Circ Cardiovasc Genet. 2013;6:400-8. (Measurement of plasma levels of atorvastatin and rosuvastatin in two cohorts [299 and 576 patients] found levels varied 45-fold and were consistently higher in Chinese and Japanese compared to European subjects and that differences could not be completely explained by racial variation in frequencies of SLCO and ABCG2 polymorphisms known to affect peak drug levels). 23876492
Liu Y, Su Q, Li L. Efficacy of short-term high-dose atorvastatin pretreatment in patients with acute coronary syndrome undergoing percutaneous coronary intervention: a meta-analysis of nine randomized controlled trials. Clin Cardiol 2013; 36: E41-8. (Metanalysis of 3 trials of high dose, short term atorvastatin in 333 patients with an acute coronary event undergoing percutaneous coronary interventions stenting found no increase in rate of serum ALT elevations [10% vs 7%], but no details provided and no mention of clinically apparent liver injury). 24038054
Wiliński J, Dabrowski M. Safety and tolerability of the use of atorvastatin 40 mg in common daily practice in short-term observation in 3,227 patients. Przegl Lek 2013; 70: 373-6. (Abstract: Prospective questionnaire study of 3227 patients treated with atorvastatin [40 mg daily] found that 0.4% had discontinued therapy because of serum aminotransferase elevations). 24052972
Wu du C. Hepatitis B virus reactivation associated with atorvastatin. Int J Infect Dis. 2013; 17: e1069-70. (48 year old man with HBsAg [HBeAg negative] and coronary artery disease had worsening of hepatitis B after 8 months of atorvastatin therapy [ALT rising from 41 to 322 U/L and HBV DNA from 3.3 to 6.8 log10 IU/mL], improving upon stopping and not worsening when treated with simvastatin). 23725984
Tikkanen MJ, Fayyad R, Faergeman O, Olsson AG, Wun CC, Laskey R, Kastelein JJ, et al.; IDEAL Investigators. Effect of intensive lipid lowering with atorvastatin on cardiovascular outcomes in coronary heart disease patients with mild-to-moderate baseline elevations in alanine aminotransferase levels. Int J Cardiol 2013; 168: 3846-52. (Post hoc analysis of the IDEAL study of 8863 patients with hypercholesterolemia treated with simvastatin [20-40 mg daily] vs atorvastatin [80 mg daily], comparing those with normal ALT levels [7782, mean=26 U/L] to those with elevated levels [1081, mean=61 U/L], found improvement in cardiovascular outcomes with atorvastatin in both the normal [12.7% vs 13.9%] and high ALT [6.5% vs 11.5%] groups, rates being higher and the effect greater in the elevated ALT cohort). 24001698
Thapar M, Russo MW, Bonkovsky HL. Statins and liver injury. Gastroenterol Hepatol (N Y) 2013; 9: 605-6. (Review of the hepatotoxicity of statins including both serum enzyme elevations and clinically apparent liver injury). 24729773
Demyen M, Alkhalloufi K, Pyrsopoulos NT. Lipid-lowering agents and hepatotoxicity. Clin Liver Dis 2013; 17: 699-714. (Review of hepatotoxicity of statins, fibrates, niacin, bile acid resins and ezetimibe). 24099026
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 cases attributed to atorvastatin [one with jaundice] for an estimated rate of 1:3693 persons treated). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents). 24552865
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology 2014; 60: 679-86. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2], and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]). 24700436
Bays H, Cohen DE, Chalasani N, Harrison SA. An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol 2014; 8 (3 Suppl): S47-57. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease and are probably safe in other forms of chronic liver disease and after liver transplantation). 24793441
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One 2014; 9: e96919. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin). 24810427
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med 2014; 12: 51. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]). 24655568
Drugs for lipids. Treat Guidel Med Lett 2014; 12 (137): 1-6. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver). 24419209
Vishwakarma P, Nehra R, Kumar A. Acute hepatic injury with atorvastatin: an unusual occurrence. Indian J Pharmacol 2014; 46: 343-4. (63 year old man developed jaundice 2 months after starting 20 mg daily of atorvastatin [bilirubin 5.2 mg/dL, ALT 1124 U/L, Alk P 214 U/L], falling to normal within a month of switching to 10 mg daily of rosuvastatin). 24987187
Bastida C, Also MA, Pericas JM, Letang E, Tuset M, Miró JM. [Rhabdomyolysis and severe hepatotoxicity due to a drug-drug interaction between ritonavir and simvastatin]. Enferm Infec Microbiol Clin 2014; 32: 579-82. Spanish. (52 year old woman with HIV infection on darunavir/ritonavir, lamivudine and raltegravir was switched from atorvastatin [40 mg] to simvastatin [80 mg] daily and developed rhabdomyolysis 3 weeks later [bilirubin 0.5 mg/dL, ALT 787 U/L, CK 34,960 U/L], possibly due to drug-drug interactions between simvastatin and ritonavir).
Ivandić E, Bašić-Jukić N. [Liver damage caused by atorvastatin and cyclosporine in patients with renal transplant]. Acta Med Croatica 2014; 68: 175-8. Croatian. (61 year old male renal transplant recipient on cyclosporine developed elevations in liver tests 3 months after starting atorvastatin for hypercholesterolemia [ALT 424 U/L, Alk P 261 U/L, bilirubin not given], which fell to normal after stopping the statin and switching from cyclosporine to everolimus). 26012156
Kalantari S, Naghipour M. Statin therapy and hepatotoxicity: appraisal of the safety profile of atorvastatin in hyperlipidemic patients. Adv Biomed Res 2014; 3: 168. (Among 206 patients started on atorvastatin in a "semi-experimental" study, "in general ALT and AST remained in the normal range"). 25221771
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig 2014; 106: 246-54. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin, and 2 pravastatin], usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths). 25075655
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf 2014; 23: 719-25. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]). 24829162
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin, and 2 lovastatin). 25754159
Carrascosa MF, Salcines-Caviedes JR, Lucena MI, Andrade RJ. Acute liver failure following atorvastatin dose escalation: is there a threshold dose for idiosyncratic hepatotoxicity? J Hepatol 2015; 62: 751-2. (85 year old woman on atorvastatin for more than a year developed jaundice after increasing dose from 40 to 80 mg daily [bilirubin 4.1 mg/dL, ALT 909 U/L, Alk P 415 U/L, CK 4753 U/L, INR 1.71], with transient worsening, but ultimate improvement and resolution). 25463547
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol 2015; 30: 155-62. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]). 25041076
Birmingham BK, Bujac SR, Elsby R, Azumaya CT, Wei C, Chen Y, Mosqueda-Garcia R, et al. Impact of ABCG2 and SLCO1B1 polymorphisms on pharmacokinetics of rosuvastatin, atorvastatin and simvastatin acid in Caucasian and Asian subjects: a class effect? Eur J Clin Pharmacol. 2015;71:341-55. (Among 96 subjects treated in an open-label, 3-way crossover study of a single oral dose of rosuvastatin [20 mg], atorvastatin [40 mg], or simvastatin [40%], Chinese and Japanese subjects had higher plasma levels than European subjects, and the differences could not be attributed entirely to hepatic transporter polymorphisms {SLCO1B1*1a and ABCG2c.421] known to be associated with higher statin levels). 25673568
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther 2016; 41: 266-72. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations). 27015878
Clarke AT, Johnson PC, Hall GC, Ford I, Mills PR. High dose atorvastatin associated with increased risk of significant hepatotoxicity in comparison to simvastatin in UK GPRD cohort. PLoS One 2016; 11: e0151587. (Analysis of the Clinical Practice Research Database of UK patients initiating statin treatment between 1997 and 2006 identified 71 of 76,411 developing liver dysfunction while on atorvastatin [0.09%] vs 101 of 164,407 on simvastatin [0.06%], rates being higher with higher [40 or 80 mg] vs lower [10 or 20 mg] doses of atorvastatin [0.44% vs 0.07%], but not with higher vs lower doses of simvastatin [0.09% vs 0.05%]). 26983033
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol 2016; 82: 823-30. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin-associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosu-], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative subjects [n=16 vs 92]). 27197051
Björnsson ES. Hepatotoxicity of statins and other lipid-lowering agents. Liver Int 2017; 37: 173-8. (Review of the hepatotoxicity of statins mentions that atorvastatin has been the most frequently implicated statin [accounting for 30-40% of cases] in drug induced liver injury estimated to arise in 1 in 17,000 users, cholestatic in 56% and with autoimmune features in 10% and rarely fatal). 27860156
Bergland Ellingsen S, Nordmo E, Lappegård KT. Recurrence and severe worsening of hepatotoxicity after reintroduction of atorvastatin in combination with ezetimibe. Clin Med Insights Case Rep. 2017;10:1179547617731375. (After an acute myocardial infarction, a 70 year old woman was treated with simvastatin in doses of 40 and 80 mg and then with atorvastatin [40 mg], but developed elevated ALT levels [69 to 123 U/L] and was switched to pravastatin, but then was switched to atorvastatin with ezetimibe and developed fatigue and weakness 2 months later [bilirubin 4.3 mg/dL, ALT 2003 U/L, Alk P 164 U/L], which resolved rapidly once atorvastatin was again discontinued). 28979175
Liang X, He Q, Zhao Q. Effect of stains on LDL reduction and liver safety: a systematic review and meta-analysis. Biomed Res Int. 2018;2018:7092414. (In a systematic review of 16 controlled trials of statins in 74,078 patients, rates of liver test abnormalities were higher with statin therapy [odds ratio, OR=1.18], but this was significant only for fluvastatin [OR=3.5] and with higher doses [40-80 mg daily] [OD=3.6] and was not significant for statins used at low or moderate doses). 29693013
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187. (A compilation of national and international databases on drug induced liver injury identified the ten top-ranking causes which included two statins, atorvastatin [ranking 3^rd^], and simvastatin [ranking 6^th^]). 30354694
Moore N, Duret S, Grolleau A, Lassalle R, Barbet V, Duong M, Thurin N, et al. Previous drug exposure in patients hospitalised for acute liver injury: a case-population study in the French National Healthcare Data System. Drug Saf. 2019;42:559-572. (Analysis of a French nationwide health database for medication use and hospitalizations for unexplained acute liver injury identified 4807 cases, 76% of which had been exposed to at least one medication in the previous 7-60 days, 263 cases [5.5%] had taken atorvastatin, but the exposed/case ratio was 15,742; 182 cases [3.8%} had taken rosuvastatin, the exposed/case ratio being 20,359; while only 10 cases had taken pyrazinamide but with an exposed/case ratio of 770). 30361989
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. 2019;210:18-28. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk). 30716508
Godinho R, Bugnon S, Gracin T, Tataw J. Severe rhabdomyolysis-induced acute kidney injury following concomitant use of Genvoya® (EVG/COBI/FTC/TAF) and simvastatin; a case report. BMC Nephrol 2019;20:69. (54 year old man with HIV infection, chronic hepatitis C, acute hepatitis A and hypercholesterolemia on simvastatin developed myalgias, weakness and worsening jaundice 10 days after switching antiretroviral regimen to a fixed combination of elvitegravir, emtricitabine, tenofovir and cobicistat a potent inhibitor of CYP 3A4 [ALT 2081 U/L, AST 7017 U/L, GGT 198 U/L, bilirubin 7.6 mg/dL, CPK 185,190 U/L and creatinine 6.1 mg/dL], improving ultimately after stopping the antiretroviral combination regimen). 30808332
Lipid-lowering drugs. Med Lett Drugs Ther. 2019;61(1565):17-24. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives, niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”). 30845106
Laube R, Liu K. An unwanted complement: rare case of potential liver injury induced by an interaction between ginseng and atorvastatin. Br J Clin Pharmacol. 2019;85:1612-1613. (82 year old man on atorvastatin [80 mg daily] for 5 years with normal ALT levels found to have elevated values 1 week after starting a herbal product with ginseng [ALT 931 U/L, Alk P 253 U/L, bilirubin 2.4 mg/dL, INR 1.1, CPK 350 U/L], resolving rapidly on stopping both the statin and ginseng which may have altered metabolism of atorvastatin by inhibition of CYP 3A4 and OATP1B1). 30980549
Hung TH, Tsai CC, Lee HF. Statin use in cirrhotic patients with infectious diseases: A population-based study. PLoS One. 2019;14:e0215839. (Analysis of the Taiwan National Health Insurance Database identified 816 patients with cirrhosis receiving statins [including atorvastatin] who were hospitalized for bacterial infections and similar number of cirrhotic controls not on statins, found a lower 30-day mortality with statins: 5.3% vs 9.8%). 31017946
Mohamed MFH, Salameh OK, Saeed AAM. Statin-induced rhabdomyolysis, acute kidney injury, and hepatitis leading to death. Am J Case Rep. 2019;20:709-712. (67 year old man with coronary artery disease developed muscle pains 2 months and jaundice 4 months after starting atorvastatin in a dose of 40 mg daily [bilirubin 7.2 mg/dL, ALT 1325 U/L, Alk P 249 U/L, CPK 18,267 U/L, creatinine 5.5 mg/dL], with progressive renal and hepatic failure; death from cardiac arrest). 31101801
Kuniyoshi N, Miyakawa H, Matsumoto K, Tsunashima H, Sekine K, Tsujikawa T, Mabuchi M, et al. Detection of anti-mitochondrial antibodies accompanied by drug-induced hepatic injury due to atorvastatin. Intern Med. 2019;58:2663-2667. (44 year old Japanese woman developed fatigue 10 months after starting atorvastatin [bilirubin 07 mg/dL, ALT 84 U/L, Alk P 1557 U/L, AMA 1:40, ANA 1:40, immunoglobulins normal], with slow recovery after stopping). 31178503
Simon TG. When less is more: dosing simvastatin in decompensated cirrhosis. Lancet Gastroenterol Hepatol. 2020;5:3-5. (Editorial in response to Pose et al [2020] discusses the possible beneficial effects of statins in patients with cirrhosis and the issue of increased rate of muscle toxicity with 40 vs to 20 mg daily). 31607676
Pose E, Napoleone L, Amin A, Campion D, Jimenez C, Piano S, Roux O, et al. Safety of two different doses of simvastatin plus rifaximin in decompensated cirrhosis (LIVERHOPE-SAFETY): a randomised, double-blind, placebo-controlled, phase 2 trial. Lancet Gastroenterol Hepatol. 2020;5:31-41. (Among 50 patients with decompensated cirrhosis treated with simvastatin [20 or 40 mg daily] and rifaximin vs placebo for 12 weeks, 3 of 16 patients on 40 mg of simvastatin developed muscle pains and marked elevations in CPK, ALT and AST, whereas the 14 patients on 20 mg did not develop signs of either muscle or liver toxicity). 31607677
Abdallah MA, Ahmed KM, Gohar A, Abdalla AO, Waqas Q, Elgouhari H, Huntington MK. Elevated liver enzymes unmask severe statin-induced muscle injury. Am J Ther. 2020;27:e420-e422. (57 year old woman with coronary artery disease developed fatigue and muscle weakness 12 months after starting atorvastatin [40 mg daily] with elevations in ALT and AST [values not provided], which did not improve with stopping and CPK values found high [5523 U/L] with anti-HMG-CoA, muscle biopsy showing necrosis without inflammation and responding to corticosteroids and IVIG). 31180927
Chapman G, Tanner S. An unusually impressive atorvastatin-induced elevation of serum alkaline phosphatase. BMJ Case Rep. 2020;13:e231839. (90 year old woman with transient ischemic attack developed abnormal liver tests 2 months after starting atorvastatin [40 mg daily] [bilirubin 0.7 mg/dL, ALT 187 U/L, Alk P 940 U/L, GGT 1189 U/L, INR 1.0, ANA and AMA negative], with slow but full recovery 1-3 months after stopping). 32047080
Menon PD, Singh T, Hubbard H, Hackman S, Sharkey FE. Cholangiolytic changes in statin-induced liver injury. Case Rep Pathol. 2020;2020:9650619. (A 58 year old Hispanic woman with diabetes developed abdomen pain and abnormal liver tests having been on atorvastatin for several years [bilirubin 1.5 mg/dL, ALT 748 U/L, Alk P 826 U/L, AMA and ANA negative, IgG 2700 mg/dL], abnormalities persisting until atorvastatin was stopped, 3 months after which liver tests fell to normal). 32099709
Courlet P, Livio F, Alves Saldanha S, Scherrer A, Battegay M, Cavassini M, Stoeckle M, et al.; Swiss HIV Cohort Study. Real-life management of drug-drug interactions between antiretrovirals and statins. J Antimicrob Chemother. 2020;75:1972-1980. (Assessment of lipid levels in persons living with HIV who were taking atorvastatin found that one-third had suboptimal lipid control despite high doses, perhaps due to drug-drug interactions including inhibition of OATP1b1 causing poor hepatic uptake of statins). 32240298
Kawasaki E, Fukuyama T, Kuriyama E, Uchida A, Sagara Y, Tamai H, Nakano Y, et al. Statin-induced autoimmune hepatitis in patients with type 1 diabetes: A report of two cases and literature review. J Diabetes Investig. 2020;11:1673-1676. (Two men, ages 46 and 54, with type 1 diabetes developed hepatitis 6 and 8 months after starting atorvastatin and rosuvastatin [bilirubin 5.1 and unknown mg/dL, ALT 1632 and 709 U/L, Alk P not given and 2055 U/L, ANA 1:80 and negative, IgG 1495 and 1857 mg/dL], both with autoimmune hepatitis-like features on liver biopsy and both with response to corticosteroid therapy). 32277861
Khan AA, Ahmed S, Mohammed A, Elzouki AY. Autoimmune-like drug-induced liver injury caused by atorvastatin and demonstration of the safety profile of pravastatin: a case report and literature review. Cureus. 2020;12:e7299. (57 year old woman was found to have abnormal liver tests 3 months after starting 40 mg of atorvastatin daily [bilirubin 7.2 mg/dL, ALT 3195 U/L, Alk P 435 U/L, ANA pos, SMA 1:640, IgG 1210 mg/dL], resolving within 3 months of stopping [SMA 1:80] and later tolerating pravastatin [dose not given]). 32313740
Hopewell JC, Offer A, Haynes R, Bowman L, Li J, Chen F, Bulbulia R, et al. Independent risk factors for simvastatin-related myopathy and relevance to different types of muscle symptom. Eur Heart J 2020;41:3336-3342. (In a combined analysis of 3 large clinical trials in patients with cardiovascular disease treated with simvastatin for a mean of 3.4 years, 171 of 58,390 participants [0.1%] developed myopathy [muscle pain and CK levels above 10 times ULN], and risk was higher with higher doses, in Asian subjects, women, and persons with higher BMI and multiple comorbidities as well as with SLCO1B1 genotype). 32702748
Weersink RA, Alvarez-Alvarez I, Medina-Cáliz I, Sanabria-Cabrera J, Robles-Díaz M, Ortega-Alonso A, García-Cortés M, et al. Clinical characteristics and outcome of drug-induced liver injury in the older patients: from the young-old to the oldest-old. Clin Pharmacol Ther. 2021;109:1147-1158. (Analysis of 882 cases of drug induced liver injury enrolled in the Spanish DILI Registry between 1994 and 2018 analyzed by 4 age groups [<65, 65-74, 75-84, ≥85 years] showed that average severity increased with older age and cases were more likely to be cholestatic, the most frequent causes being amoxicillin-clavulanate, atorvastatin, levofloxacin, ibuprofen and ticlopidine). 33179256
Balasubramanian R, Maideen NMP. HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. 2021;22:328-341. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [ator-, sim- and lo-vastatin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including atorvastatin], with specific recommendations for the most common inhibitors). 33459228
Pedraza L, Laosa O, Rodríguez-Mañas L, Gutiérrez-Romero DF, Frías J, Carnicero JA, Ramírez E. Drug induced liver injury in geriatric patients detected by a two-hospital prospective pharmacovigilance program: a comprehensive analysis using the Roussel Uclaf Causality Assessment Method. Front Pharmacol. 2021;11:600255. (Among 458 cases of drug induced liver injury in elderly patients [age 65 or older] seen at two Spanish medical centers over a 2- and 8-year period, the most frequent causes were acetaminophen [n=50], amoxicillin-clavulanate [n=42], and atorvastatin [n=37], the latter being mostly mild [65%], mean age 77 years, 51% hepatocellular, none fatal, and all except one resolving; among hospitalized subjects the estimated incidence was 37 per 10,000 defined drug-days). 33613279
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. 2021;21:120. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients). 33726685
Onfiani G, Nascimbeni F, Carubbi F. A case of statin-induced liver injury with positive rechallenge with a second statin. Is there a class effect? J Basic Clin Physiol Pharmacol. 2021;32:1151-1155. (58 year old woman on long term simvastatin therapy developed ALT elevations 2 months after dose increase from 10 mg to 20 mg daily [ALT 314 U/L] without symptoms, Alk P or bilirubin elevations which were normal 2 months after stopping but were elevated again without symptoms or jaundice 2 months after starting rosuvastatin in a dose of 5 mg daily [ALT 542 U/L], slowly falling to normal 5 months after stopping statins a second time). 33882199
Saha A, Garg A. Severe liver injury associated with high-dose atorvastatin therapy. J Investig Med High Impact Case Rep. 2021;9:23247096211014050. (71 year old man with hyperlipidemia, diabetes, hypertension and chronic renal dysfunction developed abnormal liver tests 3 months after starting pioglitazone and atorvastatin [80 mg daily], having tolerated simvastatin in doses of 20 to 40 mg daily for years [bilirubin 1.5 mg/dL, ALT 1385 U/L, Alk P 265 U/L, INR 1.0], with rapid improvement and normal tests one month after stopping both drugs, but later tolerating restarting simvastatin and pioglitazone). 33966478
Ortland I, Mirjalili M, Kullak-Ublick GA, Peymani P. Drug-induced liver injury in Switzerland: an analysis of drug-related hepatic disorders in the WHO pharmacovigilance database VigiBase^TM^ from 2010 to 2020. Swiss Med Wkly. 2021;151:w20503. (Analysis of the global VigiBase for drug induced liver injury identified 2042 cases reported from Switzerland, the most commonly implicated agents being acetaminophen, amoxicillin-clavulanate, esomeprazole, and atorvastatin). 34000058
Lu B, Sun L, Seraydarian M, Hoffmann TJ, Medina MW, Risch N, Iribarren C, et al. Effect of SLCO1B1 T521C on statin-related myotoxicity with use of lovastatin and atorvastatin. Clin Pharmacol Ther. 2021;110:733-740. (Among 233 patients with statin associated myopathy and 2342 controls selected from an aging cohort with genetic testing, the allele frequency of c.521T>C in SLCO1B1 [rs4149056] was higher in those with myopathy, C allele frequency being 14%-15% of controls compared to 17% of atorvastatin [p=0.4], 19% of lovastatin [p<0.001], and 25% of simvastatin [p<0.001] myopathy cases). 34114646
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. 2021;374:n1537. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes, rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes, while atorvastatin and lovastatin had highest risk for liver abnormalities). 34261627
Castermans A, Hias J, Van der Linden L, Spriet I, Tournoy J. [Case of hepatotoxicity of atorvastatin: the search for a possible etiology]. Tijdschr Gerontol Geriatr. 2022;53(3). Dutch. (75 year old woman with a history of liver test abnormalities while taking 20 mg of atorvastatin daily [bilirubin 0.6 mg/dL, ALT 460 U/L, Alk P 341 U/L] re-developed abnormalities on restarting 80 mg of atorvastatin 7 years later [bilirubin 0.4 mg/dL, ALT 121 U/L, Alk P 312 U/L], later tolerating rosuvastatin without liver test abnormalities).
Verma SK, Huang J, Hutchinson HG, Estevez I, Kuang K, Reynolds SL, Schneeweiss S. Statin use and severe acute liver Injury among patients with elevated alanine aminotransferase. Clin Epidemiol. 2022;14:1535-1545. (Among 149,410 adults identified in two health insurance databases who initiated statin therapy, 32 developed serious liver injury [20 per 100,000 person years] which was similar to a matched cohort of 517,200 who did not start statins [25 per 100,000 person years], and the presence of preexisting ALT elevations was not associated with subsequent development of serious liver injury [16 vs 19 per 100,000 persons years]). 36540900
Wang H, Liu S, Zhou C, Fu Y. Fatal hepatic failure following atorvastatin treatment: A case report. Medicine (Baltimore). 2023;102:e33743. (63 year old man with multiple medical conditions developed acute liver injury during a hospitalization for chest pain and 1 day after starting atorvastatin and while receiving multiple antibiotics [bilirubin 1.2 mg/dL, ALT 776 U/L, AST 112 U/L, Alk P and INR not reported], which improved within a few days of stopping but rose again after restarting atorvastatin with acute liver failure and death [ALT 4555 U/L, AST 11,400 U/L, bilirubin 3.4 mg/dL). 37171309
Kashyap K, Bisht K, Dhar M, Mittal K. Atorvastatin-induced myositis and drug-induced liver injury. J Assoc Physicians India. 2023;71:96-98. (68 year old man with coronary artery disease developed muscular weakness and pain accompanied by jaundice, 8 months after starting 80 mg of atorvastatin daily [bilirubin 13.1 mg/dL, ALT 1301 U/L, CPK 21,650 U/L], with improvement upon stopping atorvastatin). 38716533
Tse J, Natla S, Mekala R, Crumm I, Olken MH. Atorvastatin-induced autoimmune hepatitis: a case report. Cureus. 2023;15:e47807. (74 year old woman developed jaundice 20 months after restarting atorvastatin [ALT 95 U/L, Alk P 345 U/L, bilirubin 21.9 mg/dL, INR 2.1, ANA 1:160] having a history of a similar episode of liver injury while taking atorvastatin in the past; no follow up information or mention of immunosuppressive therapy). 38021877
Patel M, Fattah A, Hussaini H, Maneesha F, Ahmed Z. Drug-induced autoimmune hepatitis: an unusual adverse event of atorvastatin therapy. Cureus. 2024;16:e55809. (57 year old woman developed fatigue and pruritus 2 to 3 months after starting atorvastatin [ALT 201 U/L, Alk P 332 U/L, bilirubin 6.9 mg/dL, INR 1.2, ANA 1:180], improving with prednisone therapy but worsening upon stopping and requiring long term immunosuppression with abnormal liver tests 6 months after stopping atorvastatin). 38586640
Su FY, Li WH, Zhao XD, Han Q, Xu X, Geng T. Risk factors analysis of severe liver injury induced by statins. Horm Metab Res. 2024;56:419-423. (Among 1211 cases of statin induced liver injury reported to a Chinese database between 2013 and 2021, 157 were considered “severe” [ALT ≥400 U/L or bilirubin ≥2.0 mg/dL]; risk factors for severity included older age, combination with other drugs or herbs, and atorvastatin). 37956980
Singh H, Khalaf A, Kunkle BF, Gholami S, Lewis JH, Rangnekar AS. Atorvastatin-induced liver injury with concurrent rhabdomyolysis after a positive rechallenge. ACG Case Rep J. 2024;12:e01570. (56 year old woman developed myalgias and jaundice 4 months after starting 40 mg of atorvastatin daily [ALT 541 U/L, AST 1179 U/L, CPK 1760 U/L, Alk P 383 U/L, bilirubin 11.8 mg/dL, INR 1.3], with rapid improvement on stopping and subsequent rise after restarting atorvastatin followed by severe rhabdomyolysis [peak CPK 316,454 U/L] and renal failure with subsequent slow resolution). 39742213
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records from between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, at a rate of 1 per10,100 patients exposed to atorvastatin and 1 per 14,285 exposed to rosuvastatin). 38913369
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2024: Oct 22. [Online ahead of print]. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug induced liver injury 918 per 100,000 persons exposed, the incidence being 1:23,510 for those treated with atorvastatin).
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. (Analysis of 1284 cases of drug induced liver injury enrolled in a US prospective study identified 7 cases of rosuvastatin, which was consistent with an incidence of 1 per 16,000 persons treated with rosuvastatin compared to 1 per 10,000 with atorvastatin, and 1 per 52,000 with simvastatin). 39317916
Wang B, Huang S, Li S, Deng Y, Li Z, Wang Y, Shi X, et al. Hepatotoxicity of statins: a real-world study based on the US Food and Drug Administration Adverse Event Reporting System database. Front Pharmacol. 2025;15:1502791. (Analysis of the FDA Adverse Event Reporting System for reports of liver injury attributed to statins between 2004 and 2024 identified 14,511 instances, atorvastatin being the most frequently listed [n=7,903] followed by simvastatin [3,074], rosuvastatin [2,512], pravastatin [458], fluvastatin [262], pitavastatin [178], and lovastatin [124], fatal cases accounting for 2.5% to 5.6%). 39840096

## OTHER REFERENCE LINKS

1. Recent References on Atorvastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=atorvastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Atorvastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=atorvastatin)